# Dapsone

## OVERVIEW

### Introduction

Dapsone is a sulfonamide related drug used for the therapy of leprosy and dermatitis herpetiformis. Dapsone has been linked with rare cases of idiosyncratic liver injury, similar to that seen with the sulfonamides.

### Background

Dapsone (dap' sone) is 4,4’ diaminodiphenylsulfone and is bacteriostatic for Mycobacterium leprae. Like other sulfonamides, dapsone is believed to act by inhibition of folate synthesis. Bacteria including M. leprae are acutely sensitive to this inhibition as folate is necessary for protein, DNA and RNA synthesis. In contrast, humans are not affected by this inhibition of folate synthesis because they rely upon dietary sources of folate. Dapsone was approved for use in the United States in 1979. Current indications include leprosy and dermatitis herpetiformis. Off-label uses include prophylaxis against pneumocystis jiroveci (formerly carinii) in HIV infected patients. Dapsone is available in multiple generic forms in tablets of 25 and 100 mg. Dapsone is usually started at a low dose in the range of 50 mg daily and titrated upward to a total daily dose of 100 to 300 mg. In the therapy of leprosy, the combination of dapsone with clofazimine and rifampin is recommended for 6 or 12 months followed by monotherapy with dapsone until all signs of clinical activity are controlled and biopsies are negative for at least a year. Up-to-date and reliable information on the management of leprosy is available from the National Hansen's Disease (Leprosy) Clinical Center, Baton Rouge, LA: https://www.hrsa.gov/hansens-disease/clinical-center.html. Dapsone is also available as a topical gel for therapy of acne. Common side effects of oral dapsone include hemolysis and anemia, methemoglobinemia, nausea, abdominal pain, tinnitus, vertigo, blurred vision, headache, insomnia, and rash. Dapsone is not uncommonly associated more severe side effects including peripheral neuropathy, acute psychosis, nephrotic syndrome, acute liver injury, hemolysis, agranulocytosis, aplastic anemia, hypersensitivity reactions and a lupus-like syndrome.

### Hepatotoxicity

Dapsone, like other sulfonamides, causes a characteristic idiosyncratic liver injury that has features of drug-allergy or hypersensitivity. The typical onset is sudden development of fever and rash followed by jaundice within a few days or weeks of starting the medication. Eosinophilia or lymphocytosis are also common. The presentation can resemble acute mononucleosis and is often referred to as "sulfone syndrome" which is a variant of the "drug rash with eosinophilia and systemic symptoms" (DRESS) syndrome. Rare instances of Stevens Johnson Syndrome and Toxic epidermal necrosis can also occur with dapsone therapy, arising generally within the first 1 to 3 months of therapy. The pattern of injury is typically cholestatic or mixed and can be complicated and prolonged. Severe cholestatic forms of dapsone hepatotoxicity can result in vanishing bile duct syndrome with chronic cholestasis ultimately resulting in chronic liver failure and death. In rare instances, dapsone induced liver injury has resulted in acute hepatocellular injury and acute liver failure. However, most cases resolve rapidly, usually within 2 to 4 weeks of stopping dapsone, unless cholestasis is severe.

Likelihood score: A (well known cause of clinically apparent liver injury).

### Mechanism of Injury

The clinical pattern of injury with dapsone suggests a drug-allergy or hypersensitivity mechanism, perhaps through its metabolism to a toxic, reactive or antigenic metabolite. Studies in patients with leprosy from Asia indicate that DRESS syndrome as well as Stevens Johnson syndrome attributed to dapsone therapy are closely associated with HLA-B*13.01.

### Outcome and Management

Dapsone induced liver injury can result in acute liver failure, but most cases resolve rapidly with discontinuation of drug and full recovery is expected within 2 to 8 weeks. Severe cholestatic injury may be prolonged. Rechallenge should not be done, and patients should be told that they are allergic to sulfonamides (“sulfa-drugs”) and not receive other drugs in this class. If dapsone is considered crucial for management, attempts at desensitization can be made. Prednisone has been used to treat dapsone related liver injury with variable success, but may be particularly helpful in patients with prominent allergic features with systemic features and fever, rash, and eosinophilia.

Drug Class: Antiinfective Agents, Sulfonamides

Other Drugs in this Subclass, Leprosy Agents: Clofazimine, Rifampin

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Dapsone – Generic

DRUG CLASS

Antiinfective Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=dapsone)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Dapsone | 80-08-0 | C12-H12-N2-O2-S

## ANNOTATED BIBLIOGRAPHY

References updated: 15 January 2026

Abbreviations: ULN, upper limit of normal; SJS, Stevens Johnson syndrome; TEN, toxic epidermal necrolysis; DRESS, drug-reaction with eosinophilia and systemic symptoms.
Zimmerman HJ. Sulfonamides. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 606-9. (Expert review of the sulfonamides and sulfones published in 1999; sulfonamides are thought to cause clinically apparent liver injury in 0.5-1.0% of recipients generally with a sudden onset within 14 days of starting, often with immune allergic features and a hepatocellular or mixed pattern of injury; mortality may be as high as 10%).
Moseley RH. Sulfonamides. Hepatotoxicity of antimicrobials and antifungal agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 463-82. (Review of hepatotoxicity of antibiotics including sulfonamides).
MacDougall C. Sulfonamides, trimethoprim-sulfamethoxazole, quinolones, and agents for urinary tract infections. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1011-1021. (Textbook of pharmacology and therapeutics).
Gumbo TC. Chemotherapy of tuberculosis, mycobacterium avium complex disease and leprosy. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1077-1086. (Textbook of pharmacology and therapeutics).
Lowe J, Smith M. The chemotherapy of leprosy in Nigeria; with an appendix on glandular fever and exfoliative dermatitis precipitated by sulfones. Int J Lepr 1949; 17: 181-95. (Summary of clinical results in using sulfones in 227 patients with leprosy described "Glandular fever and exfoliative dermatitis precipitated by sulfones" in the appendix: occurring mostly in adult men, the dermatitis in 2%, glandular fever in 12% which was marked by fever, lymphadenitis, splenomegaly and jaundice in some cases: initial description of sulfone-syndrome). 15399690
Fries J, Siragenian R. Sulfonamide hepatitis. Report of a case due to sulfamethoxazole and sulfisoxazole. N Engl J Med 1966; 274: 95-7. (60 year old woman developed jaundice after 4 days of sulfamethoxazole with fever, arthralgias and rash [bilirubin 8.4 mg/dL, ALT 360 U/L, Alk P 2.5 times ULN], with positive rechallenge within 30 hours of starting sulfamethoxazole [AST 396 U/L, Alk P 1.5 times ULN]). 5901208
Dujovne CA, Chan CH, Zimmerman HJ. Sulfonamide hepatic injury. Review of the literature and report of a case due to sulfamethoxazole. N Engl J Med 1967; 277: 785-8. (Classic description of sulfonamide hepatotoxicity: case report of a 38 year old man who developed jaundice after 14 days of sulfamethoxazole [3rd exposure] with positive rechallenge; review of the literature on over 100 cases: usual latency of 1-4 weeks, shorter on rechallenge, rash and fever common). 6046676
Millikan LE, Harrell ER. Drug reactions to the sulfones. Arch Dermatol 1970; 102: 220-4. (50 year old man developed fever and cholestatic jaundice after a 4 week course of sulfone, resolving in a few weeks). 4914268
Iwarson S, Lundin P. Multiple attacks of jaundice associated with repeated sulfonamide treatment. Acta Med Scand 1979; 206: 219-22. (Four women, ages 20, 30, 35 and 68 years, who had repeated episodes of liver injury after sulfonamides with shortening of latency upon re-exposure, but no worsening of injury [usually hepatocellular] or slowing of resolution, which ranged from 4-12 weeks). 495230
Frey HM, Gershon AA, Borkowsky W, Bullock WE. Fatal reaction to dapsone during treatment of leprosy. Ann Intern Med 1981; 94: 777-9. (17 year old Burmese boy with suspected leprosy developed rash followed by fever and jaundice [bilirubin 7.0 mg/dL, ALT 700 U/L] 3 weeks after starting dapsone and thalidomide with atypical lymphocytosis, exfoliation, progressive liver failure, multiorgan failure and death). 7235421
Tomecki KJ, Catalano CJ. Dapsone hypersensitivity. The sulfone syndrome revisited. Arch Dermatol 1981; 117: 38-9. (16 year old girl developed fever and fatigue followed by jaundice beginning 2 weeks after starting dapsone [50 mg/day] for acne [bilirubin 3.6 mg/dL, ALT 560 U/L, Alk P 449 U/L, 10% eosinophils], with hemolytic anemia, responding to prednisone, and resolving within 4 weeks). 6450569
Døssing M, Andreasen PB. Drug-induced liver disease in Denmark. An analysis of 572 cases of hepatotoxicity reported to the Danish Board of Adverse Reactions to Drugs. Scand J Gastroenterol 1982; 17: 205-11. (572 reports of drug induced liver injury from 1968-78 were analyzed, representing 6% of total adverse reaction reports and 12% of those that were fatal; halothane accounted for 25% of cases, chlorpromazine 9%, sulfonamides 9%, antituberculosis agents 7%, oxyphenisatin 4% and methyldopa 2%). 6982502
Kromann NP, Vilhelmsen R, Stahl D. The dapsone syndrome. Arch Dermatol 1982; 118: 531-2. (33 year old woman developed fever and rash 2 weeks and cholestatic liver enzyme elevations [AST 241 U/L, Alk P 1341 UL, bilirubin 1.3 mg/dL, and hepatic granulomata] 4 weeks after starting dapsone, accompanied by lymphadenopathy, atypical lymphocytes and leukemoid reaction, resolving within 8 weeks of stopping). 7092282
Johnson DA, Cattau EL Jr, Kuritsky JN, Zimmerman HJ. Liver involvement in the sulfone syndrome. Arch Intern Med 1986; 146: 875-7. (49 year old woman developed fever and malaise 2 weeks after starting dapsone [bilirubin 4.5 mg/dL, AST 2540 U/L, ALk P 177 U/L]; rapid response to prednisone in ~4 weeks, review of literature and FDA reports). 3963977
Leoung GS, Mills J, Hopewell PC, Hughes W, Wofsy C. Dapsone-Trimethoprim for Pneumocystis carini pneumonia in the acquired immunodeficiency syndrome. Ann Intern Med 1986; 105: 45-8. (Experience in treating patients with known AIDS using dapsone-TMP; 6 of 15 patients had ALT elevations [peak 235 U/L] and 8 had rash, but none had jaundice). 2940954
Lawrence WA, Olsen HW, Nickles DJ. Dapsone hepatitis. Arch Intern Med 1987; 147: 175. (19 year old woman developed fever and jaundice 24 days after starting dapsone [bilirubin 9.8 mg/dL, ALT 2745 U/L, Alk P 201 U/L] with signs of acute liver failure, but ultimately spontaneous resolution). 3800520
Jayalakshmi P, Ting HC. Dapsone-induced liver necrosis. Histopathology 1990; 17: 89-91. (42 year old man developed fever, rash and jaundice 6 weeks after starting dapsone for photodermatitis [bilirubin 6.8 mg/dL, ALT >500 U/L, Alk P 656 U/L, 21% eosinophils] with liver and renal failure, dying 3 days after admission, autopsy showing extensive coagulative necrosis). 2146206
Ramanan C, Ghorpade A, Manglani PR. Dapsone syndrome. Indian J Lepr 1991; 63: 226-8.1838381
Friis H, Andreasen PB. Drug-induced hepatic injury: an analysis of 1100 cases reported to the Danish Committee on Adverse Drug Reactions between 1978 and 1987. J Intern Med 1992; 232: 133-8. (Adverse drug reaction reports in Denmark from 1978 to 1987; 62 cases [5%] were attributed to either TMP-SMZ or SMZ alone). 1506809
Mohle-Boetani J, Akula SK, Holodniy M, Katzenstein D, Garcia G. The sulfone syndrome in a patient receiving dapsone prophylaxis for Pneumocystis carinii pneumonia. West J Med 1992 Mar; 156: 303-6. (35 year old man with HIV and HBV infection developed fever and jaundice 6 weeks after starting dapsone prophylaxis [bilirubin 3.7 mg/dL, ALT 650 U/L, Alk P 229 U/L, 10% atypical lymphocytes], which began to resolve within days of stopping; review of 21 cases in the literature, all occurred within 2 months of starting, all with fever and most with jaundice). 1595261
Reeve PA, Ala J, Hall JJ. Dapsone syndrome in Vanuatu: a high incidence during multidrug treatment (MDT) of leprosy. J Trop Med Hyg 1992; 95: 266-70. (An increase in the rate of dapsone syndrome occurred with introduction of multidrug therapy of leprosy [dapsone, clofazimine, rifampin], occurring in 24% of 37 patients and with fatality rate of 11%). 1386634
Lons T, Richardet JP, Machayekhi JP, Dalbergue B, Trinchet JC. [Granulomatous hepatitis caused by dapsone]. Gastroenterol Clin Biol 1992; 16: 293. French. PMID: 1582552 (73 year old woman developed fever and weakness 5 months after starting dapsone [bilirubin 1.8 mg/dL, ALT 3.3 times ULN, Alk P 1.6 times ULN], liver biopsy showed granulomas with giant cells, symptoms and laboratory test abnormalities resolving with stopping dapsone and increasing corticosteroids).
Carr A, Tindall B, Penny R, Cooper DA. Patterns of multiple-drug hypersensitivities in HIV-infected patients. AIDS 1993; 7: 1532-3. (Survey of 108 AIDs patients for history of allergic reactions to antibiotics, 39% reported allergy to sulfonamides, often cross reactive, but not always [dapsone vs TMP-SMZ]). 8280426
Chalasani P, Baffoe-Bonnie H, Jurado RL. Dapsone therapy causing sulfone syndrome and lethal hepatic failure in an HIV-infected patient. South Med J 1994; 87: 1145-6. (34 year old woman with HIV infection developed rash, fever and jaundice 1 month after starting dapsone for P. jiroveci prophylaxis [bilirubin 3.1 rising to above 20 mg/dL, AST 1186 U/L, 15% eosinophils], with subsequent progressive injury, hepatic failure and death). 7973902
Barnard GF, Scharf MJ, Dagher RK. Sulfone syndrome in a patient receiving steroids for pemphigus. Am J Gastroenterol 1994; 89: 2057-9. (66 year old man developed fever, rash, and liver test abnormalities beginning 2 weeks after starting dapsone [peak bilirubin 4 mg/dL, ALT 550 U/L, Alk P 380 U/L], resolving within 4 weeks of stopping). 7942736
Lau G. A fatal case of drug-induced multi-organ damage in a patient with Hansen's disease: dapsone syndrome or rifampicin toxicity? Forensic Sci Int 1995; 73: 109-15. (71 year old man developed jaundice 7 weeks after starting dapsone [bilirubin 23.8 mg/dL, ALT 211 U/L, Alk P 385 U/L, eosinophils 15%] with severe rash, exfoliation, multiorgan failure and death 10 days after presentation). 7797183
Puri AS, Gupta R, Ghoshal UC, Khan E, Aggarwal R, Naik SR. Hepatic injury in sulfone syndrome: hepatitis or cholestasis? Indian J Gastroenterol 1995; 14: 20. (23 year old man developed fever, rash and jaundice 1 month after starting triple therapy for leprosy using dapsone [bilirubin 6.8 mg/dL, ALT 187 U/L, Alk P 376 U/L, 10% eosinophils], resolving after exfoliative dermatitis within 6 weeks of stopping and later tolerating rifampin and clofazimine). 7860114
Prussick R, Shear NH. Dapsone hypersensitivity syndrome. J Am Acad Dermatol 1996; 35 (2 Pt 2): 346-9. (22 year old woman developed fever, rash, and lymphadenopathy 5 weeks after starting dapsone [bilirubin 3.0 mg/dL, ALT 342 U/L, Alk P 138 U/L], responding to prednisone and resolving within 6 weeks of stopping). 8698924
Pillans PI. Drug associated hepatic reactions in New Zealand: 21 years’ experience. N Z Med J 1996; 109: 315-9. (Adverse drug reaction reports identified 943 liver injuries over 21 years in New Zealand; TMP-SMZ accounted for 29 (ranking 9th), 1 case being fatal). 8816722
Kaluarachchi SI, Fernandopulle BM, Gunawardane BP. Hepatic and haematological adverse reactions associated with the use of multidrug therapy in leprosy--a five year retrospective study. Indian J Lepr 2001; 73: 121-9. (Review of side effects of multidrug therapy of leprosy in 3333 patients identified 25 cases of toxic hepatitis, usually within first 3 months of starting, some related to rifampin but details not provided). 11579648
Itha S, Kumar A, Dhingra S, Choudhuri G. Dapsone induced cholangitis as a part of dapsone syndrome: a case report. BMC Gastroenterol 2003; 3: 21. (40 year old man developed fever, rash, and jaundice 3 weeks after starting dapsone [100 mg/day] [bilirubin 14.4 mg/dL, ALT 127 U/L, Alk P 141 U/L, 6% eosinophils], with subsequent desquamation and improvement on stopping). 12911838
Lee KB, Nashed TB. Dapsone-induced sulfone syndrome. Ann Pharmacother 2003; 37: 1044-6. (42 year old HIV-positive man developed fever, rash, and jaundice 4 weeks after starting dapsone [100 mg/day] [peak bilirubin 5.7 mg/dL, ALT 255 U/L, Alk P 2078 U/L], resolving within 8 weeks of stopping). 12841817
Slatore CG, Tilles SA. Sulfonamide hypersensitivity. Immunol Allergy Clin North Am 2004; 24: 477-90, vii. PMID: 15242722 (Review of mechanisms of hypersensitivity to sulfonamides).
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl 2004; 10: 1018-23. (Among ~50,000 liver transplants done in the US between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, 3 of which were attributed to sulfasalazine and 1 to TMP-SMZ). 15390328
Björnsson E, Jerlstad P, Bergqvist A, Olsson R. Fulminant drug-induced hepatic failure leading to death or liver transplantation in Sweden. Scand J Gastroenterol 2005; 40: 1095-101. (Among 103 cases of fulminant drug induced liver injury reported to a Swedish registry between 1966 and 2002, 6 cases were attributed to TMP-SMZ, 3 to sulfonamides and 1 to sulfasalazine [~10% overall]). 16165719
Garcia Rodriguez LA, Ruigomez A, Jick H. Fulminant drug-induced hepatic failure leading to death or liver transplantation in Sweden. Scand J Gastroenterol 2005; 40: 1095-1101. (Among 103 cases of fulminant drug induced liver injury reported to a Swedish registry between 1966 and 2002, 6 cases were attributed to TMP-SMZ, 3 to sulfonamides and 1 to sulfasalazine [~10% overall]). 16165719
Alves-Rodrigues EN, Ribeiro LC, Silva MD, Takiuchi A, Fontes CJ. Dapsone syndrome with acute renal failure during leprosy treatment: case report. Braz J Infect Dis 2005; 9: 84-6. (39 year old woman developed fever 23 days after starting dapsone [100 mg/day] and one week later developed jaundice [direct bilirubin 1.8 mg/dL, ALT 137 U/L] and renal failure, with slow recovery on prednisone after stopping). 15947852
Abidi MH, Kozlowski JR, Ibrahim RB, Peres E. The sulfone syndrome secondary to dapsone prophylaxis in a patient undergoing unrelated hematopoietic stem cell transplantation. Hematol Oncol 2006; 24: 164-5.16639690
(51 year old woman with acute myelogenous leukemia and hematopoietic cell transplantation developed fever and hemolytic anemia followed by rash and jaundice on dapsone therapy [bilirubin 7 mg/dL, ALT 203 U/L], dying 3 weeks later) .
Björnsson E, Olsson R. Suspected drug-induced liver fatalities reported to the WHO database. Dig Liver Dis 2006; 38: 33-8. (Survey of drug induced liver fatalities reported to WHO database between 1968-2003 revealed 4690 reports – 89% from the US; 21 drugs were associated with more than 50 cases each, including TMP-SMZ [ranking 10th]). 16054882
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, et al; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, 9 were due to TMP-SMZ, which ranked 4th as a cause). 18955056
Ranawaka RR, Mendis S, Weerakoon HS. Dapsone-induced haemolytic anaemia, hepatitis and agranulocytosis in a leprosy patient with normal glucose-6-phosphate-dehydrogenase activity. Lepr Rev 2008;79:436-40. (21 year old man developed fever and agranulocytosis 5 months after starting multidrug therapy of leprosy [bilirubin 2.4 mg/dL, ALT 282 U/L], which resolved within 1 month of stopping and he later tolerated long term rifampin and clofazimine therapy). 19274991
Sheen YS, Chu CY, Wang SH, Tsai TF. Dapsone hypersensitivity syndrome in non-leprosy patients: a retrospective study of its incidence in a tertiary referral center in Taiwan. J Dermatolog Treat 2009; 20: 340-3. (Among 361 patients without leprosy treated with dapsone over a 54 month period, hypersensitivity syndrome developed in 6 [2%], including 4 women and 2 men, arising after 8-36 days with fever and rash; 5 had liver involvement [bilirubin 1.2 to 4.7 mg/dL, ALT 62 to 1064 U/L, Alk P 297-1072 U/L], none fatal, all resolving symptomatically within 30 days). 19954390
Devarbhavi H, Dierkhising R, Kremers WK, Sandeep MS, Karanth D, Adarsh CK. Single-center experience with drug-induced liver injury from India: causes, outcome, prognosis, and predictors of mortality. Am J Gastroenterol 2010; 105: PMID: 2396-404. (313 cases of drug induced liver injury were seen over a 12 year period at a large hospital in Bangalore, India; dapsone accounted for 17 cases [5.4%] of which 2 were fatal, and TMP-SMZ accounted for 7 cases [2.2%], but none were fatal).
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury including 12 due to sulfonamides [9%], 9 due to SMZ/TMP, and 3 due to sulfasalazine). 20949552
Devarbhavi H, Karanth D, Prasanna KS, Adarsh CK, Patil M. Drug-Induced liver injury with hypersensitivity features has a better outcome: a single-center experience of 39 children and adolescents. Hepatology 2011; 54: 1344-50. (Between 1997 and 2010, 450 cases of drug induced liver injury were seen at a single center in India, including 45 cases in children [9%], among whom the most common causes were antituberculosis drugs [n=22, 50% mortality], anticonvulsants [phenytoin 10, carbamazepine 6], and dapsone 4; others included 1 case each due to TMP-SMZ, ciprofloxacin, amoxicillin and Ayuryedic agents). 21735470
Garcia A, Yi NJ, Lee KB, Lee JM, Choi YR, Suh SW, You T, et al. Fulminant hepatitis linked to dapsone hypersensitivity syndrome requiring urgent living donor liver transplantation: a case report. Pediatr Transplant 2014; 18: E240-5. (12 year old girl developed fever and rash 3 weeks after starting dapsone, which was followed by jaundice and liver failure [bilirubin 1.8 rising to 19.6 mg/dL, ALT 131 U/L, Alk P not given, INR rising to 2.6], undergoing urgent living-donor liver transplantation, explant showing submassive necrosis). 25156688
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, including 39 attributed to antimicrobial agents, but none to dapsone or TMP/SMP). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 31 cases were attributed to TMP/SMZ and only 2 cases to dapsone). 25754159
Schulkes KJ, Tervaert JW, Rijken F, Haas LE. Dapsone hypersensitivity syndrome not related to G6PD deficiency. BMJ Case Rep 2015; 2015. pii: bcr2015212742. (55 year old woman developed fever, cough and rash 4 weeks after starting dapsone [bilirubin 0.9 mg/dL, ALT 150 U/L, Alk P 213 U/L, INR 1.4] with pulmonary infiltrates, resolving with prednisone therapy within 4 weeks of stopping dapsone). 26682839
Sawlani KK, Chaudhary SC, Singh J, Raja DC, Mishra S, Goel MM. Dapsone-induced pure red cell aplasia and cholestatic jaundice: A new experience for diagnosis and management. J Res Pharm Pract. 2016;5:215-8.. (30 year old woman developed jaundice and pruritus 3 months after starting dapsone for suspected dermatitis herpetiformis [bilirubin 24.3 mg/dL, ALT 345 U/L, Alk P 2840 U/L, INR 1.0] with pure red cell aplasia [Hgb 2.6 g/dL] and yet recovered spontaneously within 3 months of stopping). 27512715
Tangamornsuksan W, Lohitnavy M. Association between HLA-B*1301 and dapsone-induced cutaneous adverse drug reactions: a systematic review and meta-analysis. JAMA Dermatol. 2018;154:441-446.. (Review of 3 studies of dapsone induced severe cutaneous adverse reactions that included appropriate controls, 86% of 111 cases vs only 13% of controls had at least one allele of HLA-B*13:01). 29541744
Kathi PR, Tama M, Ehrinpreis M, Mutchnick M, Westerhoff M, Mowers J, Fontana RJ. Vanishing bile duct syndrome arising in a patient with HIV infection sequentially treated with trimethoprim/sulfamethoxazole and dapsone. Clin J Gastroenterol. 2020;13:276-280.. (58 year old African American man with HIV infection developed pruritus within 2 days and jaundice by 8 days of starting TMP-SMZ [bilirubin 11.9 mg/dL, ALT 1519 U/L, Alk P 1345 U/L] which resolved slowly after stopping but recurred 9 months later within 7 days of starting dapsone [bilirubin 16.9 mg/dL, ALT 282 U/L, Alk P 1353 U/L] which did not improve upon stopping, resulting in persistent jaundice, intractable pruritus, and liver biopsy showing vanishing bile duct syndrome resulting in hepatic failure and death 2 years later). 31317370
Kang DY, Yun J, Lee SY, Koh YI, Sim DW, Kim S, Nam YH, et al; Korean Severe Cutaneous Adverse Reactions Consortium. A nationwide study of severe cutaneous adverse reactions based on the multicenter registry in Korea. J Allergy Clin Immunol Pract. 2021;9:929-936.e7.. (Among 745 cases of severe cutaneous adverse reactions enrolled in a Korean registry between 2010 and 2015, none of 384 cases of SJS/TEN were attributed to dapsone compared to 15 of 361 of DRESS (ranking 5^th^), but none were fatal compared to 4% of cases attributed to other causes). 32961314
Fontana RJ, Kleiner DE, Chalasani N, Bonkovsky H, Gu J, Barnhart H, Li YJ, et al. The impact of patient age and corticosteroids in patients with sulfonamide hepatotoxicity. Am J Gastroenterol. 2023;118:1566-1575.. (Among 105 cases of sulfonamide-induced liver injury enrolled in a prospective U.S. database between 2004 and 2020, 93 were due to trimethoprim-sulfamethoxzole, 9 to sulfasalazine, 2 to dapsone and 1 to sulfadiazine). 36848311
Wung CH, Wang CW, Lai KC, Chen CB, Chen WT, Hung SI, Chung WH; Taiwan Severe Cutaneous Adverse Reaction Consortium. Current understanding of genetic associations with delayed hypersensitivity reactions induced by antibiotics and anti-osteoporotic drugs. Front Pharmacol. 2023;14:1183491.. (Review of the literature on the HLA associations associated with severe cutaneous adverse reactions mentions that HLA-B*13:01 is a strong risk factor for both SJS and DRESS syndrome due to dapsone in Asian populations). 37180708
Alhusari L, Pigliacampi M, Alshawabkeh Y, Hamdani T, Bsiso T, Mustafa B, Dial L. Dapsone-induced methemoglobinemia presenting concomitantly with COVID-19 pneumonia and pulmonary embolism: a case report. Cureus. 2024;16:e51830.. (A 73 year old man with bullous pemphigoid treated with dapsone developed severe respiratory failure due to COVID-19 infection and pneumonia and was found to have methemoglobinemia, no mention of liver injury or ALT levels). 38327942
Bessone F, Hernandez N, Medina-Caliz I, García-Cortés M, Schinoni MI, Mendizabal M, Chiodi D, et al. Drug-induced liver injury in Latin America: 10-year experience of the Latin American DILI (LATINDILI) Network. Clin Gastroenterol Hepatol. 2025;23:89-102.. (Among 483 cases of drug-induced liver injury enrolled in a prospective Latin American database, 2 were attributed to dapsone [0.5%], while 3 of 1600 cases [0.2%] were reported from a concurrent US database). 38992407
Ali N, Abughazal M, Honeini R, Honeini R. Recognizing drug-induced methemoglobinemia in the emergency setting: a case of topical dapsone toxicity. Cureus. 2025;17:e92342.. (21 year old woman with acne taking topical dapsone for 6 months developed headaches and shortness of breath and was found to have hypoxia and methemoglobinemia which resolved with stopping the cream, no mention of ALT or hepatoxicity). 41103871

## OTHER REFERENCE LINKS

1. Recent References on Dapsone: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=dapsone/AE+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI+OR+hepatitis,+toxic%5BMH%5D))

2. Trials on Dapsone: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=dapsone)